# Benzbromarone

## OVERVIEW

### Introduction

Benzbromarone is a nonpurine xanthine oxidase inhibitor used for the treatment of gout, but never approved for use in the United States because of concerns over reports of acute liver injury and deaths with its use.

### Background

Benzbromarone (benz broe' ma rone) is a nonpurine inhibitor of xanthine oxidase that shares no structural homology to allopurinol or to hypoxanthine, but rather is a structural homologue of amiodarone and dronedarone. Therapy leads to lowering of serum uric acid levels within a few weeks, and chronic therapy has been shown to decrease uric acid levels into target levels of less than 6 mg/dL and to decrease acute gouty attacks. Benzbromarone was approved for use in Europe and Asia, but was not licensed in the United States because of concerns over hepatotoxicity. Benzbromarone was withdrawn by its sponsor in 2003 because of continuing concerns over hepatotoxicity.

### Hepatotoxicity

Liver test abnormalities have been reported to occur rarely during benzbromarone therapy, in only 0.1% of patients in clinical trials. Furthermore, it was used widely for many years without reports of hepatotoxicity until the late 1980s, after which several cases of acute liver injury and acute liver failure during benzbromarone therapy were published. Hepatic injury arises after 1 to 6 months of therapy presenting with jaundice and fatigue, usually with a hepatocellular pattern of enzyme elevations. Immunoallergic symptoms (rash, fever) are uncommon. Low levels of autoantibodies have been reported in some cases with liver histology demonstrating chronic active hepatitis, particularly if benzbromarone is not stopped promptly. Upon stopping therapy, resolution is typically within 1 to 3 months. The hepatic injury from benzbromarone is similar to that reported with benzarone, a structurally related drug that was used for peripheral vascular disease, but also withdrawn also because of concerns over hepatotoxicity.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of benzbromarone hepatotoxicity is believed to be due to its hepatic metabolism by CYP 2C9 and possible effects of the parent compound or its metabolites on mitochondrial function. Benzbromarone is a benzofuran and shares structural similarities with benzarone and amiodarone, all three of which affect mitochondrial function.

### Outcome and Management

Acute cases of benzbromarone and benzarone hepatotoxicity have varied in severity, but a high proportion of cases developed acute liver failure leading to death or emergency liver transplantation. Chronic liver injury and vanishing bile duct syndrome related to these agents have not been reported. Recurrence is common and can be severe with rechallenge which should be avoided.

Drug Class: Antigout Agents

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Benzbromarone | 3562-84-3 | C17-H12-Br2-O3 | Benzbromarone chemical structure
Amiodarone | 1951-25-3 | C25-H29-12-N-O3 | Amiodarone chemical structure
Benzarone | 1477-19-6 | C17-H14-O3
Dronedarone | 141626-36-0 | C31-H45-CIN2-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 05 September 2017

Grosser T, Smyth E, FitzGerald GA. Pharmacology of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 994-1004. (Textbook of pharmacology and therapeutics).
Babany G, Larrey D, Pessayre D, Degott C, Rueff B, Benhamou JP. Chronic active hepatitis caused by benzarone. J Hepatol 1987; 5: 332-5. (61 year old woman developed jaundice after more than a year of benzarone therapy [bilirubin 4.4 mg/dL, ALT 38 times ULN, Alk P 1.5 times ULN], with recovery on stopping, but patient started medication again on her own twice, each time redeveloping jaundice; liver biopsy showed bridging fibrosis and chronic hepatitis; eventually recovered completely; SMA 1:500 but ANA negative). 3429840
Nakad A, Azzouzi K, Gerbaux A, Delcourt A, Sempoux C, Tamo F, Rahier J, Geubel AP. [Hepatitis due to benzarone: a second case] Gastroenterol Clin Biol 1990; 14: 782-4. (70 year old woman developed jaundice 1 month after starting benzarone [a benzofurane used for peripheral vascular disease and available in France since 1964] with bilirubin 6 mg/dL, ALT 400 U/L, Alk P 415 U/L; positive rechallenge after another month of therapy with bilirubin rising to 7.1 mg/dL, ALT 1015 U/L, Alk P 392 U/L, slow recovery). 2262129
Sepulchre D, De Plaen JL, Geubel AP. [Drug-induced hepatitis due to benzarone (Fragivix): apropos of a clinical case report] Acta Gastroenterol Belg 1990; 53: 499-503. (46 year old woman developed fatigue and jaundice one month after starting benzarone [bilirubin 11.3 mg/dL, ALT 1340 U/L, Alk P 400 U/L], resolution in several months; recurrence 14 days after restarting [bilirubin 16 mg/dL, ALT 1012 U/L, Alk P 157 U/L and hyperglobulinemia], resolving within 2 months of stopping). 2130580
van der Klauw MM, Houtman PM, Stricker BH, Spoelstra P. Hepatic injury caused by benzbromarone. J Hepatol 1994; 20: 376-9. (68 year old woman developed malaise and jaundice 3 months after switching from allopurinol to benzbromarone [bilirubin 4.9 mg/dL, ALT 793 U/L, Alk P 217 U/L], full recovery and positive rechallenge 6 weeks after restarting therapy). 8014449
Gehenot M, Horsmans Y, Rahier J, Geubel AP. Subfulminant hepatitis requiring liver transplantation after benzarone administration. J Hepatol 1994; 20: 842. (62 year old woman developed jaundice and fatigue 10 weeks after starting benzarone therapy for venous insufficiency [bilirubin 2.1 rising to 8.0 mg/dL, ALT 160 rising to 3792 U/L], with subsequent hepatic failure and death, autopsy showing confluent necrosis). 7930488
Hautekeete ML, Henrion J, Naegels S, deNeve A, Alder M, Deprez C, Devis G, Kloppel G. Severe hepatotoxicity related to benzarone: a report of three cases with two fatalities. Liver 1995; 15: 25-9. (2 women and 1 man, ages 35, 67 and 68 years, developed jaundice 1.5-5 months after starting benzarone for peripheral vascular disease [bilirubin 4.6-29 mg/dL, ALT 819-1810 U/L, Alk P 164-282 U/L]; 1 died, 1 transplanted, 1 developed cirrhosis). 7776854
Wagayama H, Shiraki K, Sugimoto K, et al. Fatal fulminant hepatic failure associated with benzbromarone. J Hepatol 2000; 32: 874. (62 year old man developed jaundice 5 months after starting benzbromarone with bilirubin rising to 31.2 mg/dL, AST 1369 U/L, progressing to hepatic failure and death; lymphocyte stimulation test negative). 10845680
Suzuki T, Suzuki T, Kimura M, Shinoda M, Fujita T, Miyake N, Yamamoto S, Tashiro K. A case of fulminant hepatitis, possibly caused by benzbromarone. Nippon Shokakibyo Gakkai Zasshi 1001; 98: 421-5. (58 year old man developed jaundice after 7 months of benzbromarone therapy [bilirubin 7.9 mg/dL, ALT 1168, Alk P 792 U/L], progressing to hepatic failure, lymphocyte stimulation test negative). 11400273
Arai M, Yokosuka O, Fujiwara K, Kojima H, Kanda T, Hirasawa H, Saisho H. Fulminant hepatic failure associated with benzbromarone treatment: a case report. J Gastroenterol Hepatol 2002; 17: 625-6. (53 year old woman developed jaundice 2 months after starting benzbromarone for hyperuricemia [bilirubin 23.3 mg/dL, ALT 1140 U/L and Alk P 123 U/L], with progressive downhill course despite stopping the medication; living donor liver transplantation done and explant showed massive necrosis). 12084041
Kaufmann P, Trk M, Hnni A, Roberts P, Gasser R, Krhenbhl S. Mechanisms of benzarone and benzbromarone-induced hepatic toxicity. Hepatology 2005; 41: 925-35. (In vitro studies showing effects of benzarone and benzbromarone on hepatic mitochondrial function, inhibiting beta-oxidation and uncoupling oxidative phosphorylation, causing hepatocellular apoptosis). 15799034
Lee MH, Graham GG, Williams KM, Day RO. A benefit-risk assessment of benzbromarone in the treatment of gout. Was its withdrawal from the market in the best interest of patients? Drug Saf 2008; 31: 643-65. (Benzbromarone was introduced in 1970s and available in ~20 countries, never in the US, withdrawn by sponsor in 2003 because of hepatotoxicity; among 11 published cases, 9 were fatal; estimated rate of hepatotoxicity 1:17,000; authors argue for its use in refractory gout). 18636784
Haring B, Kudlich T, Rauthe S, Melcher R, Geier A. Benzbromarone: a double-edged sword that cuts the liver? Eur J Gastroenterol Hepatol 2013; 25: 119-21. (77 year old woman developed jaundice 4 months after starting benzbromarone [bilirubin 9.5 mg/dL, ALT 1771 U/L, Alk P 194 U/L, ANA positive], with progressive hepatic failure and death 53 days after presentation). 23196726
Kumagai J, Kanda T, Yasui S, Haga Y, Sasaki R, Nakamura M, Wu S, et al. Autoimmune hepatitis following drug-induced liver injury in an elderly patient. Clin J Gastroenterol 2016; 9: 156-9. (77 year old Japanese man developed liver test abnormalities 8 months after starting benzbromarone for gout [bilirubin not given, ALT 353 U/L, Alk P 433 U/L] which worsened over the next several months while continuing therapy [bilirubin 4.3 mg/dL, albumin 2.2 g/dL], eventually developing weakness, ascites, elevated IgG [2636 mg/dL] and ANA [titer not given], with slow recovery on stopping benzbromarone and starting ursodiol and prednisone). 27170297

## OTHER REFERENCE LINKS

1. Recent References on Benzbromarone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Benzbromarone/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Benzbromarone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Benzbromarone)